# Progestins

Desogestrel, Dydrogesterone, Levonorgestrel, Medroxyprogesterone, Megestrol, Norethindrone, Norgestrel, Norgestimate, Progesterone

## OVERVIEW

### Introduction

Progesterone is the naturally occurring hormone that is actively secreted by the ovary and interacts with progesterone receptors in the reproductive tract, mammary gland and central nervous system. Progesterone and the progestins have been used alone or in combination with estrogens in oral contraceptives, as therapy of postmenopausal symptoms, for secondary amenorrhea, abnormal uterine bleeding, endometriosis and progesterone sensitive cancers. High doses of progestins can cause liver test abnormalities and can occasionally lead to clinical apparent acute liver injury.

### Background

Progesterone (proe jes' ter one) is the naturally occurring progestin which is secreted by the ovary and has a multitude of actions on many organs, but predominantly on the reproductive tract, mammary glands and central nervous system. Large amounts of progesterone are produced in women by the corpus luteum during the second half of the menstrual cycle, which inhibits the effects of estrogen on endometrial proliferation and results in a secretory status of the endometrium in preparation for implantation of a fertilized egg. If pregnancy does not occur, the corpus luteum regresses and levels of progesterone fall, triggering menstruation and resetting of the ovarian cycle. Progesterone also affects mammary glands and is required for their development and maintenance and, in the central nervous system, increases body temperature and ventilator responses. Progesterone also has androgenic and antiestrogenic effects and causes an increase in basal insulin levels, enhances fat deposition and decreases bone turnover. Modifications of the progesterone molecule can produce compounds with better absorption and pharmacokinetics and more focused and specific activities.

Progestins are compounds with biological activities similar to progesterone. Progestins developed for clinical use include desogestrel, dydrogesterone, levonorgestrel, medroxyprogesterone, megestrol, 19-nortestosterone, norethindrone, norgestrel and norgestimate, among others. Many of these progestins are used in combination with estrogens in oral contraceptives. In addition, some are used alone as contraceptive agents and to treat secondary amenorrhea, abnormal uterine bleeding, endometriosis, infertility and premature labor. Progestins have also been used to treat progesterone sensitive cancers (endometrial, renal, breast), and as therapy of anorexia and cachexia due to cancer chemotherapy or the acquired immunodeficiency syndrome (AIDS). Progestins used without estrogens include (with common brand names and year of approval in the United States): medroxyprogesterone (Provera and others: 1959), megestrol (Megase: 1971) and norethindrone (Camila, Errin, Micronor, Aygestin: 1973). Common side effects of progestin therapies include nausea, headaches, anxiety, weight gain, edema and breast tenderness and engorgement.

### Hepatotoxicity

High doses of progestins can cause liver enzyme elevations that generally rise after 1 to 2 weeks of treatment and consist largely of serum aminotransferase elevations without changes in alkaline phosphatase or bilirubin. These abnormalities are generally short lived and resolve rapidly with dose modification or discontinuation. These elevations may be more frequent when progestins are administered with high doses of estrogens or tamoxifen. Isolated case reports of symptoms with serum aminotransferase elevations and even jaundice during progestin therapy have been published, but the relationship to the hormonal therapy has not always been clear. In some instances, the liver injury was attributed to a progestin releasing intrauterine device (IUD). Finally, rare instances of cholestasis with bland hepatic injury that is typical of estrogen induced liver injury have been reported with use of progestins alone. The fact that progesterone derivatives can be metabolized to estrogenic compounds makes it possible that these cases of cholestatic jaundice are actually due to estrogens rather than the progestin molecules.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which progesterone therapy leads to liver injury is not known. Semi-synthetic progesterones may be metabolized to estrogenic compounds that might be responsible for the rare instances of cholestatic jaundice reported with progesterone only therapy.

### Outcome and Management

The rare instances of liver injury reported during progestin therapy have invariably been self-limiting and have resolved completely with stopping the progesterone preparation. Clearly documented fatal cases have not been published. Cross sensitivity to estrogen therapy has not been demonstrated in patients developing jaundice during progesterone therapy, but might be expected.

References to the safety and hepatic injury associated with progesterone and the progestins are given together after this introductory section. The safety and hepatic injury due to estrogenic agents and estrogen containing birth control pills are described in the overview section on Estrogens and Oral Contraceptives.

Drug Class: Obstetrical and Gynecological Agents; Hormonal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Medroxyprogesterone – Generic, Provera® [Oral], Depo-Provera® [Injection]

DRUG CLASS

Hormonal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Progestins)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Progesterone | 57-83-0 | C21-H30-O2
Desogestrel | 54024-22-5 | C22-H30-O
Dydrogesterone | 152-62-5 | C21-H28-O2
Levonorgestrel | 797-63-7 | C21-H28-O2
Medroxyprogesterone | 520-85-4 | C22-H32-O3
Megestrol | 3562-63-8 | C22-H20-O3 C22-H30-O3
Norethindrone | 68-22-4 | C20-H26-O2
Norgestrel | 6533-00-2 | C21-H28-O2
Norgestimate | 35189-28-7 | C23-H31-N-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2020

Abbreviations: OCC, oral contraceptive; IUD, intrauterine device.

Zimmerman HJ. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 555-88. (Expert review of hepatotoxicity published in 1999; while progesterone has no demonstrable adverse effects on hepatic function, synthetic progestins have been linked to cases of cholestatic jaundice, particularly when used in higher than contraceptive doses).
Chitturi S, Farrell GC. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 707-22. (Review of hepatotoxicity of female sex hormones published in 2007 states that progestin-only contraceptives or high dose progestin regimens used in breast cancer may rarely produce cholestasis).
Levin ER, Vitek WS, Hammes SR. Progestins: Estrogens, progestins and the female reproductive tract. In, Brunton LL, Hilal-Dandan R, Knollman B, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-32. (Textbook of pharmacology and therapeutics).
Perez-Mera RA, Shields CE. (1962). Jaundice associated with norethindrone acetate therapy. N Engl J Med. (35 year old woman developed jaundice 1 year after starting norethindrone and shortly after dose escalation [bilirubin 6.5 mg/dL], liver biopsy showing cholestasis, resolving after stopping).
Routier G, Corette L, Dannas P. (1967). J Sc Med Lille.
Werner T. (1969). Z Gastroenterol. (63 year old woman with metastatic breast cancer developed jaundice 7 weeks after starting high doses of norethisterone [bilirubin 10.4 mg/dL, ALT 33 IE, Alk P 2 times ULN], liver biopsy showing bland cholestasis, resolving slowly within 4 months of stopping).
Adlercreutz H, Tenhunen R. (1970). Some aspects of the interaction between natural and synthetic female sex hormones and the liver. Am J Med. (Review of the hepatic effects of synthetic estrogens and progestins states that "intrahepatic cholestasis and jaundice... have been reported only for progestogens with the 19-norsteroid configuration").
Metreau JM, Dhumeaux D, Berthelot P. (1972). Oral contraceptives and the liver. Digestion. (Review of the hepatic effects of oral contraceptives).
Langlands AO, Martin WM. (1975). Jaundice associated with norethisterone-acetate treatment of breast cancer. Lancet. (Among 107 patients with advanced breast cancer treated with norethisterone, 6 developed jaundice after 6-57 weeks of treatment [bilirubin 1.8-7.6 mg/dL, ALT 192-287 U/L, Alk P 12-80 KAU], resolving after stopping; literature review suggests that jaundice arises in 2-3% of progesterone treated patients).
Kreek MJ. (1987). Female sex steroids and cholestasis. Semin Liver Dis. (Review of cholestasis of pregnancy and estrogens: "many synthetic progestins are metabolized to estrogenic compounds").
Meijers WH, Willemse PHB, Sleijfer D, Mulder NH, Grond J. (1986). Hepatocellular damage by cyproterone acetate. Eur J Cancer Clin Oncol. (Among 20 women with advanced breast cancer treated with cyproterone [an antiandrogen with progestative effects], 3 developed serum enzyme elevations at least 10 times ULN [GGT and AST] after 12 weeks, which resolved rapidly upon stopping).
Riippa P, Kauppila A. (1984). Sundströ, Vihko R. Hepatic impairment during simultaneous administration of medroxyprogesterone acetate and tamoxifen in the treatment of endometrial and ovarian carcinoma. Anticancer Res. (In a trial of the combination of tamoxifen and high doses of medroxyprogesterone, 4 of 30 patients developed marked increases in ALT [80-600 IU/L] within 1-3 months, resolving within 1-2 months of stopping without jaundice and with minimal symptoms).
Foitl DR, Hyman G, Lefkowitch JH. (1989). Jaundice and intrahepatic cholestasis following high-dose megestrol acetate for breast cancer. Cancer. (Woman with metastatic breast cancer was treated with high doses of megestrol [800-1200 mg/day] intermittently and presented 1 month later with liver test abnormalities [bilirubin 1.0 rising to 11.2 mg/dL, ALT 160 U/L, Alk P 324 U/L], with fluctuating levels of bilirubin and fever until her death 26 days after admission).
Hannaford PC, Kay CR, Vessey MP, Painter R, Mant J. (1997). Combined oral contraceptives and liver disease. Contraception. (Analysis of two large prospective studies of OCC use from the UK [>200,000 women-years] found low rate of liver disease and no association with OCC use; in one study, a possible increased risk for mild liver disease during first 4 years of use ).
Altintaş E, Oğuz D, Kaçar S, Ozderin Y, Sezgin O, Zengin NI. (2004). Dydrogesterone-induced hepatitis and autoimmune hemolytic anemia. Turk J Gastroenterol. (26 year old woman had recurrent episodes of hepatitis occurring after taking dydrogesterone for 18 and 15 days [bilirubin 31 rising to 51.1 mg/dL, ALT 204 to 704 U/L, Alk P 144, ANA 1:40], resolving within 1 month of stopping).
Anand V, Gorard DA. (2005). Norethisterone-induced cholestasis. QJM. (Two cases of cholestatic jaundice during norethisterone therapy: 18 and 34 year old women on norethisterone for 2 weeks and 2 years developed jaundice and itching [bilirubin 2.5 and 1.9 mg/dL, ALT 540 and 179, Alk P 102 and 532 U/L], with recovery after stopping, one treated with prednisone).
Faddah LM, Al-Rehany MA, Abdel-Hamid NM, Bakeet AA. (2005). Oxidative stress, lipid profile and liver functions in average Egyptian long term depo medroxy progesterone acetate (DMPA) users. Molecules. (Among 80 women on medroxyprogesterone [given by depo injection every 3 months] for 1-4 years, there were no consistent differences in mean ALT [15-20 U/L], Alk P [64-71 U/L] or bilirubin [0.49-0.54 mg/dL] levels compared to controls).
Molinari M, Watt KD, Kruszyna T, Nelson R, Walsh M, Huang WY, Nashan B, Peltekian K. (2006). Acute liver failure induced by green tea extracts: case report and review of the literature. Liver Transpl. (44 year old woman developed jaundice 4 months after starting green tea extract [720 mg/day] for weight loss [bilirubin 13.1 rising to 43.2 mg/dL, ALT 3583 U/L, GGT 112 U/L], undergoing liver transplantation 17 days after admission; patient was also on progesterone injections for contraception).
Jimenez-Saenz M, Martinez-Sanchez C. (2007). Green tea extracts and acute liver failure: the need for caution in their use and diagnostic assessment. Liver Transpl. (Letter in response to Molinari [2006] indicating that progesterone may have contributed to the injury and describing a 22 year old woman who developed jaundice 2 weeks after starting progesterone [bilirubin 13.5 mg/dL ALT 1584 U/L], with resolution on stopping).
Ushijima K, Yahata H, Yoshikawa H, Konishi I, Yasugi T, Saito T, Nakanishi T, et al. (2007). Multicenter phase II study of fertility-sparing treatment with medroxyprogesterone acetate for endometrial carcinoma and atypical hyperplasia in young women. J Clin Oncol. (Among 45 women with endometrial hyperplasia or carcinoma treated with medroxyprogesterone for up to 3 years, 5 developed liver enzyme elevations, but few details provided).
Bigrigg A, Evans M, Gbolade B, Newton J, Pollard L, Szarewski A, Thomas C, et al. (1999). Depo Provera. Position paper on clinical use, effectiveness and side effects. Br J Fam Plann. (Expert review of medroxyprogesterone given im every 12 weeks as a form of progesterone only birth control claims that it is "the most effective reversible contraceptive available" and that major side effects are menstrual irregularity [70%], weight gain [in 70%, averaging 2 kg per year] and mood changes; no mention of hepatotoxicity or jaundice).
Tuomikoski P, Aittomä K, Mikkola TS, Ropponen A, Ylikorkala O. (2008). Effect of oral and transdermal hormone therapy on hyaluronic acid in women with and without a history of intrahepatic cholestasis of pregnancy. Am J Obstet Gynecol. (20 women with and 20 without a history of cholestasis of pregnancy were treated with transdermal contraceptive estrogens and progestins; no patient developed liver test abnormalities, jaundice or itching).
Bakry S, Merhi ZO, Scalise TJ, Mahmoud MS, Fadiel A, Naftolin F. (2008). Depot-medroxyprogesterone acetate: an update. Arch Gynecol Obstet. (Review of the chemistry, mechanism of action, clinical efficacy and safety of medroxyprogesterone states: "Very few studies have evaluated the possibility of hepatotoxicity using Depo-Provera").
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 2 cases were attributed to an estrogen containing preparation).
Franco Hidalgo S, Prieto de Paula JM, Salado Valdivieso I. (2009). Gastroenterol Hepatol. (24 year old woman developed ALT elevations without symptoms 8 days after starting medroxyprogesterone [ALT 1062 U/L, bilirubin and Alk P not provided], which fell to normal within 3 weeks of stopping; identified 13 cases of hepatotoxicity from progesterone in French and Spanish registries, characterized mostly as aminotransferase elevations without jaundice).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, ethinylestradiol with levonorgestrel accounted for 43 cases [ranking 27th], with an adjusted odds ratio of 1.9 compared to controls).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen between 1997 and 2008 at a large hospital in Bangalore, India, 1 case was attributed to an OCC).
Elouni B, Ben Salem C, Zamy M, Ganne N, Beaugrand M, Bouraoui K, Biour M. (2010). Cytolytic hepatitis possibly related to levonorgestrel/ethinylestradiol oral contraceptive use: 2 case reports. Ann Pharmacother. (Two women, ages 28 and 29, developed marked ALT elevations with no jaundice or Alk P elevations 11 and 8 months after starting OCCs, ALT levels increasing [from 7 to 31 times ULN and from 2 to 23 times ULN] as long as OCCs were continued, and resolving within 3-4 weeks once stopped).
Winner B, Peipert JF, Zhao Q, Buckel C, Madden T, Allsworth JE, Secura GM. (2012). Effectiveness of long-acting reversible contraception. N Engl J Med. (Among 7486 women receiving reversible contraception followed for up to 5 years, there were 334 unintended pregnancies [4.55 per 100 women-years] and rates were lower with IUDs or implants than with OCC, patch or ring; adverse events were not discussed).
Nelson A, Apter D, Hauck B, Schmelter T, Rybowski S, Rosen K, Gemzell-Danielsson K. (2013). Two low-dose levonorgestrel intrauterine contraceptive systems: a randomized controlled trial. Obstet Gynecol. (Among 2,885 women randomized to receive one of two levonorgestrel releasing IUDs, pregnancy rates were similar [0.33 vs 0.31] as were adverse events; no mention of ALT elevations, jaundice or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to estrogens or OCCs).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino RA, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Summary of 176 published cases of drug induced liver injury from 9 South American countries implicated a total of 53 drugs, 4 cases being due to estrogens, progestins or birth control pills, all of which were from Chile).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 [0.3%] were attributed to oral contraceptives and one to estrogen).
Eisenberg DL, Schreiber CA, Turok DK, Teal SB, Westhoff CL, Creinin MD, ACCESS IUS Investigators. (2015). Three-year efficacy and safety of a new 52-mg levonorgestrel-releasing intrauterine system. Contraception. (Among 1751 women given a levonorgestrel-releasing IUD the accumulative pregnancy rate was 0.55 [6 pregnancies, 4 ectopic] and adverse events most commonly resulting in discontinuation were expulsion, bleeding, acne and mood swings; no mention of ALT elevations or hepatotoxicity).
Loulergue P, Coriat R, Mir O. (2015). Recurrent transaminitis induced by oral contraceptives during HIV infection. Ann Pharmacother. (45 year old woman with HIV infection on a successful antiretroviral regimen developed abnormal liver tests 1 month after starting OCC [levonorgestrel/ethinyl estradiol: 150/30 mcg], with normal bilirubin and Alk P but ALT 17 times ULN, resolving within a month of stopping and 2 years later developed a similar syndrome [ALT 12 times ULN] 2 weeks after starting another OCC [norgestrel/ethinyl estradiol: 500/50 mcg], resolving within 1 month of stopping).
Choudhary NS, Bodh V, Chaudhari S, Saraf N, Saigal S. (2017). Norethisterone related drug induced liver injury: a series of 3 cases. J Clin Exp Hepatol. (3 women with vaginal bleeding, ages 27, 43 and 52 years, were found to have marked serum aminotransferase elevations without symptoms or jaundice 3 weeks to 2 months after starting norethisterone [bilirubin 0.2-1.0 mg/dL, ALT 614-1122 U/L, Alk P 89-151 U/L], improving promptly with discontinuation and recurring with rechallenge in one patient).
Cheema HI, Gupta A. (2017). Levonorgestrel-releasing intrauterine device-related acute liver injury. Case Rep Gastroenterol. (24 year old woman developed abdominal pain 2 months after insertion of levonorgestrel-releasing IUD [bilirubin 11.2 mg/dL, ALT 3,243 U/L, Alk P 166 U/L], which resolved within 60 days of withdrawal of the IUD).
(2018). Choice of contraceptives. Med Lett Drugs Ther. (Concise review of the efficacy and tolerance of currently available of contraceptives concludes that intrauterine devices and etonogestrel implants are the most effective reversible contraceptive methods; no discussion of hepatic adverse events).
Stannov SU, Ries A, Bang UC. (2019). Hepatotoxicity induced by a second-generation combined oral contraceptive: case report and review of the literature. Eur J Contracept Reprod Health Care. (24 year old woman developed fatigue and elevated liver tests having been on ethinyl estradiol/levonorgestrel [30/150 mcg] OCC for 2 years, ALT rising from 154 U/L to ~680 U/L with continued OCC use, falling with temporary stopping and rising with restarting, finally falling to normal after discontinuation).
Teal SB, Turok DK, Chen BA, Kimble T, Olariu AI, Creinin MD. (2019). Five-year contraceptive efficacy and safety of a levonorgestrel 52-mg intrauterine system. Obstet Gynecol. (Among 1751 women [ages 16 to 45 years] given levonorgestrel intrauterine device, successful placement was achieved in 1714 [98%] and the pregnancy yearly rate was 0.15 to 0.20%, while adverse events included vaginal bacterial and fungal infections, acne, nausea and vomiting, dyspareunia, headache, pelvic pain, breast tenderness, anxiety, depression, mood changes, weight gain and bleeding; no mention of ALT elevations, jaundice or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Progestins: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Progestins+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Progestins: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Progestins)